# Trimipramine

## OVERVIEW

### Introduction

Trimipramine is a tricyclic antidepressant used in the therapy of major (endogenous) as well as reactive (exogenous) depression. In clinical trials, trimipramine therapy was not associated with an increased rate of elevations in serum aminotransferase levels, and it has yet to be linked to instances of clinically apparent acute liver injury.

### Background

Trimipramine (trye mip' ra meen) is a tricyclic antidepressant that is believed to act by enhancing serotonergic and dopaminergic neurotransmission. Like most tricyclic antidepressants, trimipramine is a weak inhibitor of serotonin, norepinephrine and dopamine reuptake, but also has direct antagonist activity for some serotonin and adrenergic receptors. Trimipramine has been shown to alleviate symptoms of depression, both in patients with neurotic or situation depression as well as those with major, endogenous depression. Trimipramine was approved for use in the United States in 1979 and is still clinically available, although now not widely used. Trimipramine is available as capsules of 25, 50 and 100 mg generically and under the brand name Surmontil. The typical initial dosage in adults is 75 mg daily in divided doses, which can be modified to once daily and increased in total dose based upon efficacy and tolerance to as highly as 150 to 200 mg once daily. Common side effects are diarrhea, nausea, vomiting, fatigue, drowsiness, headache, insomnia, weight gain and sexual dysfunction. Rare potential side effects include increased suicide risk, cardiac arrhythmias, urinary retention and acute serotonin syndrome.

### Hepatotoxicity

In clinical trials, liver test abnormalities were uncommon in patients taking trimipramine (<1%) and generally no more frequent than in placebo or comparator arm recipients. No instances of acute, clinically apparent liver injury attributed to trimipramine have been reported. Most other tricyclic antidepressants in clinical use have been associated with occasional instances of acute liver injury, usually arising within 2 to 8 weeks of starting therapy. The pattern of serum enzyme elevations varied from hepatocellular to cholestatic and autoimmune features were uncommon. Immunoallergic features (rash, fever, eosinophilia) can occur, but are not prominent. Most cases of acute liver injury due to tricyclic antidepressants are mild-to-moderate in severity and resolve within one to three months. Acute liver failure due to tricyclic antidepressants has been described, but is very rare. No such cases have been linked to trimipramine use but it is rarely used.

Likelihood score: D (possible rare cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism by which trimipramine might cause liver injury is not known. Trimipramine is metabolized at least in part by the liver, but it has not been linked to significant drug-drug interactions.

### Outcome and Management

The serum aminotransferase elevations that occur on amoxapine therapy are usually self-limited and do not require dose modification or discontinuation of therapy. No instances of acute liver failure or vanishing bile duct syndrome due to trimipramine have been reported. There is no information on cross sensitivity to liver injury between trimipramine and other tricyclic antidepressants, but switching to another class of agents (such as the selective serotonin reuptake inhibitors) is probably prudent.

Drug Class: Antidepressant Agents

Other Drugs in the Subclass, Tricyclics: Amitriptyline, Amoxapine, Clomipramine, Desipramine, Doxepin, Imipramine, Nortriptyline, Protriptyline

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Trimipramine – Generic, Surmontil®

DRUG CLASS

Antidepressant Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Trimipramine)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Trimipramine | 739-71-9 | C20-H26-N2

## ANNOTATED BIBLIOGRAPHY

References updated: 05 April 2020

Abbreviations: MAO inhibitor, monoamine oxidase inhibitor; SSRI, selective serotonin reuptake inhibitor; SNRI, serotonin and norepinephrine reuptake inhibitor.

Zimmerman HJ. Antidepressants. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 493-8. (Expert review of hepatotoxicity published in 1999, trimipramine is listed as a tricyclic antidepressant with a very low incidence of hepatotoxicity).
Larrey D. Hepatotoxicity of psychotropic drugs and drugs of abuse. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 2nd ed. New York: Informa Healthcare USA, 2007, pp. 443-62. (Review of hepatotoxicity published in 2007; mentions that trimipramine, like other imipramine antidepressants, has been implicated in rare cases of acute hepatitis).
O'Donnell JM, Bies RR, Shelton RC. Drug therapy of depression and anxiety disorders. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 267-77. (Textbook of pharmacology and therapeutics).
Salzmann MM. (1965). A controlled trial with trimipramine, a new anti-depressant drug. Br J Psychiatry. (Among 27 depressed patients treated with either imipramine or trimipramine for an unstated duration, response rates were better with trimipramine; no description of side effects was provided).
Burke BV, Sainsbury MJ, Mezo BA. (1967). A comparative trial of amitriptyline and trimipramine in the treatment of depression. Med J Aust. (Among 26 patients with severe depression treated with either amitriptyline or trimipramine for 4 weeks, only 19 could complete the study and efficacy and side effects were similar with the two agents; no mention of ALT elevations or hepatotoxicity).
Young JP, Lader MH, Hughes WC. (1979). Controlled trial of trimipramine, monoamine oxidase inhibitors, and combined treatment in depressed outpatients. Br Med J. (Among 135 patients with depression treated with trimipramine, an MAO inhibitor or both for 6 weeks, trimipramine alone was more effective than the combination or the MAO inhibitor alone; side effects were not specifically addressed and no mention of ALT elevations or hepatotoxicity).
Settle EC, Ayd FJ. (1980). Trimipramine: twenty years' worldwide clinical experience. J Clin Psychiatry. (Review of the 20 year clinical experience with trimipramine [largely in Europe] before its approval in the US in 1979 mentions that side effects are similar to those with other tricyclics, the most common being sedation, dry mouth, tremor, headaches and, more rarely, excitation and agitation; no mention of ALT elevations or hepatotoxicity).
Rifkin A, Saraf K, Kane J, Ross D, Klein DF. (1980). A comparison of trimipramine and imipramine: a controlled study. J Clin Psychiatry. (Among 38 hospitalized patients with depression treated with trimipramine or imipramine for 3 weeks, clinical efficacy was similar, but side effects were less with trimipramine; no mention of ALT elevations or hepatotoxicity; 10 patients did not complete the study due to "uncooperativeness", clinical deterioration or adverse reactions).
Assalian P, Rosengarten MD, Phillips R. (1985). A comparative trial of the antidepressant, anxiolytic, and cardiovascular effects of trimipramine and doxepin in depressed hospitalized patients. J Clin Psychiatry. (Among 25 hospitalized patients with depression treated with trimipramine or doxepin for 4 weeks, results of monitoring of laboratory tests were not provided).
Cournoyer G, de Montigny C, Ouellette J, Langlois R, Elie R, Caille G, le Morvan P. (1987). A comparative double-blind controlled study of trimipramine and amitriptyline in major depression: lack of correlation with 5-hydroxytryptamine reuptake blockade. J Clin Psychopharmacol. (Among 34 patients with major depression treated with trimipramine or amitriptyline for 21 days, routine laboratory test results did not change in either group).
Cassidy S, Henry J. Fatal toxicity of antidepressant drugs in overdose. Br Med J (Clin Res Ed) 1987; 295(6605): 1021-4. Erratum in Br Med J (Clin Res Ed) 1987; 295(6610): 1382. (Analysis of prescription rates and overdose fatality reports in the UK between 1975 and 1984 found the highest fatal toxicity indices for tricyclic antidepressants [38 deaths per million] compared to MAO inhibitors [27], with high rates of amitriptyline [46], nortriptyline [39], imipramine [28] and trimipramine [28]).
Lapierre YD. (1989). A review of trimipramine. 30 years of clinical use. Drugs. (Summary of more than 25 trials of trimipramine in comparison to placebo and other antidepressants found the side effect profile similar to other tricyclic antidepressants; no mention of ALT elevations or hepatotoxicity).
Bender S, Olbrich HM, Fischer W, Hornstein C, Schoene W, Falkai P, Haarmann C, et al., Trimipramine Study Group. (2003). Antipsychotic efficacy of the antidepressant trimipramine: a randomized, double-blind comparison with the phenothiazine perazine. Pharmacopsychiatry. (Among 95 patients with acute schizophrenia treated with trimipramine or perazine for 36 days, the antipsychotic effect of the phenothiazine was greater; no mention of changes in ALT levels or hepatotoxicity).
Wehmeier PM, Kluge M, Maras A, Riemann D, Berger M, Kohnen R, Dittmann RW, et al. (2005). Fluoxetine versus trimipramine in the treatment of depression in geriatric patients. Pharmacopsychiatry. (Among 41 elderly patients with major depression treated with trimipramine or fluoxetine for 6 weeks, both efficacy and side effects were similar; one patient on trimipramine developed abnormal ALT levels, but specifics and outcome were not provided).
Gutscher K. (2013). Rauber-Lü, Haller M, Braun M, Kupferschmidt H, Kullak-Ublick GA, Ceschi A. Patterns of toxicity and factors influencing severity in acute adult trimipramine poisoning. Br J Clin Pharmacol. (Over an 18 year period, 230 cases of suspected trimipramine overdose were reported to a Swiss Toxicology Registry, mostly due to suicide attempt, symptoms being somnolence [61%], tachycardia [19%], coma [18%] and convulsions [6%], with fatal outcome in 3 patients [8.4-25 g doses] caused by cardiovascular collapse; no mention of liver manifestations or hepatic failure).
Lucena MI, Carvajal A, Andrade RJ, Velasco A. (2003). Antidepressant-induced hepatotoxicity. Expert Opin Drug Saf. (Review of hepatotoxicity of antidepressants; antidepressant use has increased markedly between 1992 and 2002, accounting for 5% of cases of hepatotoxicity; SSRIs are less likely to cause injury than tricyclics and MAO inhibitors; trimipramine is not mentioned).
Degner D, Grohmann R, Kropp S. (2004). RüE, Bender S, Engel RR, Schmidt LG. Severe adverse drug reactions of antidepressants: results of the German multicenter drug surveillance program AMSP. Pharmacopsychiatry. (Analysis of adverse drug reactions reported from 1993-2000 in 35 psychiatric hospitals; 0.3% of trimipramine recipients had a severe adverse event which was hepatic in approximately one-third, these rates being similar to the overall rates of tricyclics).
DeSanty KP, Amabile CM. (2007). Antidepressant-induced liver injury. Ann Pharmacother. (Review of drug induced liver injury and reports of injury from MAO inhibitors, SSRIs, tricyclics and atypical agents; no specific discussion of trimipramine).
Reuben A, Koch DG, Lee WM, Acute Liver Failure Study Group. (2010). Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury, including 4 from psychotropic agents [quetiapine, nefazodone, fluoxetine, venlafaxine], but none were linked to tricyclic antidepressants).
Park SH, Ishino R. (2013). Liver injury associated with antidepressants. Curr Drug Saf. (Review of drug induced liver injury due to antidepressants including SSRIs; trimipramine is not discussed).
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. (2013). Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, one being attributed to an SSRI [venlafaxine], but none to a tricyclic antidepressant).
Voican CS, Corruble E, Naveau S, Perlemuter G. (2014). Antidepressant-induced liver injury: a review for clinicians. Am J Psychiatry. (Review of the frequency and clinical features of drug induced liver injury due to antidepressants; imipramine, desipramine and amitriptyline are discussed, but not trimipramine).
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A, Chirino R, et al. (2014). Profile of idiosyncratic drug induced liver injury in Latin America. An analysis of published reports. Ann Hepatol. (Systematic review of literature of drug induced liver injury in Latin American countries published from 1996 to 2012 identified 176 cases, only one of which was attributed to an antidepressant [amitriptyline] and none to a MAO inhibitor, SSRI or SNRI).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al., United States Drug Induced Liver Injury Network. (2015). Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 20 cases [2%] were attributed to antidepressants including 9 due to SNRIs [7 to duloxetine, 1 each to nefazodone and trazodone], 5 to bupropion, 5 to SSRIs [3 to escitalopram, and 1 each to fluoxetine and sertraline], and only 1 to tricyclics [imipramine], but none to trimipramine).
Woo HJ, Kim HY, Choi ES, Cho YH, Kim Y, Lee JH, Jang E. (2015). Drug-induced liver injury: A 2-year retrospective study of 1169 hospitalized patients in a single medical center. Phytomedicine. (Among 1169 inpatients seen at a single Korean referral medical center over a 2 year period, 11 developed suspected drug induced liver injury, 6 attributed to dietary supplements and 5 to conventional drugs including 2 antidepressants [minocycline, donepezil, warfarin, gabapentin/milnacipran, and antihistamines]).
Voican CS, Martin S, Verstuyft C, Corruble E, Perlemuter G, Colle R. (2016). Liver function test abnormalities in depressed patients treated with antidepressants: a real-world systematic observational study in psychiatric settings. PLoS One. (Among 321 psychiatric inpatients, only 116 [36%] had liver tests performed and only 18 during therapy with an antidepressant, 3 of which were suspected to have drug induced liver injury, 1 each with escitalopram, venlafaxine and amitriptyline, all without jaundice and 2 without symptoms, all 3 resolving).
Friedrich ME, Akimova E, Huf W, Konstantinidis A, Papageorgiou K, Winkler D, Toto S, et al. (2016). Drug-induced liver injury during antidepressant treatment: results of AMSP, a drug surveillance program. Int J Neuropsychopharmacol. (Among 184,234 psychiatric inpatients from 80 hospitals, 149 cases [0.08%] of drug induced liver injury were reported including 71 of 50,201 patients treated with tricyclics, 18 of 11,876 receiving trimipramine and 2 of 2,016 receiving nortriptyline).
Gahr M, Zeiss R, Lang D, Connemann BJ, Hiemke C, Schönfeldt-Lecuona C. (2016). Drug-Induced liver injury associated with antidepressive psychopharmacotherapy: an explorative assessment based on quantitative signal detection using different MedDRA terms. J Clin Pharmacol. (Using data on adverse drug reaction reports from the Uppsala Monitoring Center of WHO, there were higher relative hepatotoxicity reports for nefazodone, agomelatine, many tricyclics and mirtazapine).
Chen VC, Lin CF, Hsieh YH, Liang HY, Huang KY, Chiu WC, Lee Y, McIntyre RS, et al. (2017). Hepatocellular carcinoma and antidepressants: a nationwide population-based study. Oncotarget. (Among almost 50,000 cases of hepatocellular carcinoma registered in the Taiwan National Health Insurance Research Database, the rate of antidepressant use was lower than in approximately 250,000 matched controls from the database).
Ferrajolo C, Scavone C, Donati M, Bortolami O, Stoppa G, Motola D, Vannacci A, et al., DILI-IT Study Group. (2018). Antidepressant-Induced Acute liver injury: a case-control study in an Italian inpatient population. Drug Saf. (Among 179 cases of hospitalizations for unexplained acute liver injury enrolled in an Italian prospective study between 2010 and 2014, 17 had been exposed to antidepressants including citalopram [n=4], sertraline [n=3], amitriptyline [n=3] and paroxetine [n=2], clomipramine [n=1] and amitriptyline [n=1]).
Billioti de Gage S, Collin C, Le-Tri T, Pariente A, Bégaud B, Verdoux H, Dray-Spira R, et al. (2018). Antidepressants and hepatotoxicity: a cohort study among 5 million individuals registered in the French National Health Insurance Database. CNS Drugs. (Among 5 million persons identified in a national French health insurance database who started an antidepressant between 2010 and 2015, 382 developed serious liver injury resulting in hospitalization, rates per 100,0000 persons-years being 19 for SSRIs, 22 venlafaxine, 13 duloxetine, and 33 mirtazapine; conventional tricyclics and MAO inhibitors not discussed).
Pladevall-Vila M, Pottegård A, Schink T, Reutfors J, Morros R, Poblador-Plou B, Timmer A, et al. (2019). Risk of acute liver injury in agomelatine and other antidepressant users in four European countries: a cohort and nested case-control study using automated health data sources. CNS Drugs. (Analysis of data sources from 4 European countries identified 3.2 million persons initiating antidepressant therapy among whom there was no increased risk for acute liver injury for agomelatine compared to citalopram, an SSRI with a low rate of hepatotoxicity).
(2020). Drugs for depression. Med Lett Drugs Ther. (Concise review of the mechanism of action, clinical efficacy, safety and costs of drugs for depression, mentions that tricyclics and MAO inhibitors remain valuable alternatives for treatment of moderate to severe depression, despite concerns about their safety; hepatotoxicity is mentioned only for nefazodone [now rarely used because of severe hepatotoxicity] and duloxetine [in heavy drinkers]).
Ueberberg B, Frommberger U, Messer T, Zwanzger P, Kuhn J, Anghelescu I, Ackermann K, et al. (2020). Drug-induced liver injury (DILI) in patients with depression treated with antidepressants: a retrospective multicenter study. Pharmacopsychiatry. (Among 329 psychiatric inpatients with depression seen at 6 psychiatric centers in Germany, 17 [5%] had serum aminotransferase elevations but none had clinically apparent liver injury, most commonly implicated drugs included mirtazapine, agomelatine, citalopram and venlafaxine).

## OTHER REFERENCE LINKS

1 Recent References on Trimipramine: from PubMed.gov (https://www.ncbi.nlm.nih.gov/pubmed?cmd=search&pubmedfilters=true&term=(Trimipramine%2FAE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice%2FCI+OR+bile+duct+diseases%2FCI+OR+liver%2FDE+OR+liver+diseases%2FCI)+AND+(%221900%2F1%2F1%22%5BEDat%5D%3A%222999%2F12%2F31%22%5BEDat%5D))
2 Trials on Trimipramine: from ClinicalTrials.gov (https://www.clinicaltrials.gov/ct2/results?term=Trimipramine)